# Turmeric

## OVERVIEW

### Introduction

Turmeric is a spice and popular botanical product derived from the roots of the plant Curcuma longa found mostly in India and Southern Asia. Turmeric has an intense yellow color and distinct taste and is used as a dye as well as a spice in the preparation of curry. Turmeric and its purified extract curcumin are also used medically for their purported antiinflammatory and antioxidant effects to treat a wide variety of conditions and for general health and wellness. Turmeric and curcumin have been associated with a low rate of transient serum enzyme elevations during therapy and, while having a long history of safety, some turmeric products have recently been implicated in several dozen instances of clinically apparent acute liver injury.

### Background

Turmeric (tur mer' ik) is a widely used herbal product derived from the roots of Curcuma longa, a perennial plant belonging to the ginger family (Zingiberaceae) that is native to India but grown throughout Southern Asia and in Central America. Extracts of the rhizomes of turmeric contain volatile oils and curcuminoids (such as curcumin, demethoxycurcumin and others) which are believed to be the active antiinflammatory components of the herb and are often collectively referred to as curcumin. Curcumin comprises between 1% and 6% by dry weight of whole turmeric extracts, other components being starch, fats, proteins, fiber, vitamins, minerals, and water. The antiinflammatory effects of turmeric and curcumin are thought to be mediated by inhibition of leukotriene synthesis. Curcumin has also been reported to have antineoplastic effects, mediated perhaps by inhibition of intracellular kinases. Turmeric has been used in traditional Indian (Ayurvedic) medicine to treat many conditions including indigestion, upper respiratory infections and liver diseases. Turmeric and curcumin are under active evaluation as antiinflammatory and antineoplastic agents, for treatment of diabetes and hyperlipidemia and as therapy of liver diseases including nonalcoholic steatohepatitis (NASH). The scientific bases for the purported effects of turmeric are not well established and rigorous proof of its efficacy in any medical condition is lacking. Commercial preparations of turmeric and curcumin vary widely in curcuminoid content. The recommended daily dose varies widely (100 to >1,000 mg daily), depending on the preparation used (curcuminoids vs turmeric extract), formulation (tablets, liquid, root extract, tea) and indications. Side effects are uncommon and mild but may include dermatitis and gastrointestinal upset.

### Hepatotoxicity

Both turmeric and curcumin were considered to be generally safe and for many years had not been linked to instances of liver injury in any consistent way. Studies of its use in various diseases showed low rates of transient and asymptomatic serum enzyme elevations during therapy, but without instances of clinically apparent acute liver injury. Indeed, turmeric was evaluated as a potential therapy of acute and chronic liver injury, and although its efficacy and safety were not clearly shown, therapy with turmeric and curcumin did not seem to worsen the preexisting liver conditions. Recently, isolated case reports and small case series of liver injury arising during use of turmeric dietary supplements have been published. Initially, these episodes were attributed to other exposures that might have accounted for the injury or possible contaminants in the commercial turmeric products. One reason given for the safety and lack of hepatotoxicity of curcumin was that it is poorly absorbed by the oral route, and it was unclear whether there was adequate systemic exposure to achieve any of the purported beneficial or adverse effects of turmeric or curcumin.

Importantly, means of increasing the bioavailability of curcumin were developed using piperine (black pepper) or lipid nanoparticle delivery methods to increase absorption. These high bioavailability forms of purified curcumin were subsequently linked to several cases of liver injury and mentioned as a possible cause of outbreaks of acute hepatitis with jaundice in Italy. The clinical features of the liver injury attributed to high bioavailable forms of curcumin have recently become better defined. The latency to onset of liver injury has varied from a few weeks to as long as eight months but was typically 1 to 4 months. The onset was insidious with fatigue, nausea and poor appetite followed by dark urine and jaundice. Rash and fever were absent or mild. Laboratory tests at onset typically showed marked elevations in serum aminotransferase levels (often above 1000 U/L) with only mild increases in alkaline phosphatase. Jaundice occurred, particularly if the agent was continued. While signs of hypersensitivity were not prominent, many patients developed autoantibodies, and the clinical syndrome and histological features sometimes resembled autoimmune hepatitis. Prednisone has been used to treat severe cases of turmeric hepatotoxicity but is probably not needed as recovery is rapid once the herbal product is discontinued. While reports of acute liver failure has been attributed to turmeric, most cases resolved completely without evidence of chronic injury or bile duct loss. The hepatocellular pattern of injury and frequency of jaundice suggest that fatal instances might occur at a rate of 10% of jaundiced cases, particularly if the product is not discontinued promptly.

Turmeric appears to have become the most common cause of clinically apparent, herbal-related liver injury in the United States. While most cases are attributed to highly bioavailable forms of curcumin, cases also have been described with use of unadulterated ground turmeric powder and even with turmeric herbal teas. The incidence of clinically apparent liver injury from turmeric is not known but is probably very rare, in the range of 1:10,000 to 1:100,000 persons exposed.

Likelihood score: A (recently established as a well-documented cause of clinically apparent liver injury).

### Mechanism of Injury

The acute hepatotoxicity caused by turmeric appears to be due to an idiosyncratic injury, perhaps immunologically mediated. Recent reports have shown a close association of turmeric induced liver injury with the HLA allele B*35:01, which was found in over 70% of cases compared to 10% to 15% of controls. This association suggests that the injury is linked to the immune system and perhaps the interaction of curcumin with the HLA molecule that leads to T cell recognition of a self-antigen on liver cells or to curcumin adducts present on liver cell membranes. The HLA-B* 35:01 allele is also linked to liver injury due to green tea (Camellia sinensis), Garcinia cambogia, and fo-ti (Polygonum multiflorum). These 4 herbs all have bioactive constituents that are polyphenols.

## Outcome and Management

Most cases of acute hepatic injury from turmeric resolve within 1 to 3 months of stopping the medication. In some instances, however, the injury is severe and unremitting, leading to acute liver failure and either death or need for liver transplantation. A severe outcome is more likely if turmeric is continued after the appearance of symptoms and signs of liver injury. There appears to be no cross sensitivity to hepatic injury between turmeric and other herbal products. However, reexposure to turmeric should be avoided as recurrence and more severe liver injury can occur with rechallenge.

Drug Class: Herbal and Dietary Supplements (https://www.ncbi.nlm.nih.gov/books/n/livertox/HerbalDietarySuppl/)

## CASE REPORTS

### Case 1. Acute hepatitis with jaundice attributed to turmeric.(1)

A 57 year old woman with recurrent urinary tract infections, migraine headaches, and osteoarthritis developed fatigue, nausea, abdominal pain, and anorexia, followed by itching, dark urine, and jaundice. Because of a recurrence of cystitis, she had received a 7-day course of nitrofurantoin 4 months previously and a 7-day course of cephalexin a few weeks previously. Because of persistence of symptoms, she started an over-the-counter preparation of turmeric (Nature’s Way Turmeric, 500 mg once daily) 2 to 3 weeks before onset of symptoms. She had no history of liver disease, did not drink alcohol, and had no risk factors for viral hepatitis. Her other medications included rizatriptan, salbutamol, vitamin C and D, and a multivitamin. On presentation, her serum bilirubin was 9.1 mg/dL, ALT 1425 U/L, AST 1374 U/L, and alkaline phosphatase 250 U/L and she was admitted to a hospital for evaluation. The INR was 1.3 and albumin 3.7 g/dL. Tests for hepatitis A, B, and C were negative. The ANA was positive (1:640), but SMA and AMA were negative and IgG levels were normal (1170 mg/dL). Abdominal ultrasound showed a right renal stone without hydronephrosis and normal appearing liver without evidence of biliary obstruction or gallstones. A liver biopsy showed acute inflammation and necrosis with eosinophils; plasma cells were not prominent and there was no fibrosis. Turmeric had been stopped and her liver tests improved rapidly without specific therapy (see Table). Serum bilirubin levels fell into the normal range within 6 weeks and aminotransferase levels within 3 months of stopping turmeric. When seen in follow up a year after onset, she was asymptomatic, and all liver tests were normal.

#### Key Points

Medication: | Turmeric (500 mg once daily)
Pattern: | Mixed (R=13.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 weeks
Recovery: | Complete within 2 months
Other medications: | Rizatriptan, salbutamol, vitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Started Turmeric (500 mg daily)
3 weeks | -1 week | Developed symptoms of fatigue, nausea
4 weeks | 0 | Stopped turmeric
5 weeks | 7 days | 1425 | 250 | 9.1 | Admitted
| 9 days | 1145 | 306 | 11.5 | Liver biopsy
6 weeks | 14 days | 747 | 268 | 8.1 | Discharged
7 weeks | 21 days | 466 | 292 | 4.8
9 weeks | 34 days | 95 | 183 | 2.5
| 48 days | 40 | 170 | 1.4
| 3 months | 34 | 136 | 1.1
| 1 year | 18 | 104 | 0.7
Upper Limit of Normal | | 50 | 125 | 1.2

#### Comment

A middle aged woman developed acute, icteric hepatitis 2 to 3 weeks after starting turmeric for recurrent urinary tract infections that had not responded to nitrofurantoin or cephalosporins. The liver injury began to improve within 1-2 weeks of stopping the turmeric and without other specific therapy. The turmeric product tested positive for curcumin and was negative for other potentially toxic herbal products as well as black pepper. The patient was homozygous for HLA-B*35:01, an HLA allele closely linked to liver injury from several herbal products including turmeric, green tea, Fo-ti, and garcinia. The clinical features of female sex, hepatocellular liver injury, low levels of autoantibodies, lack of rash and fever, and rapid improvement on stopping the product are typical of turmeric induced liver injury. While she had also been exposed to nitrofurantoin and cephalexin, the latency to onset was not compatible with those two antibiotics and cephalexin is a very rare cause of liver injury which is typically cholestatic.

### Case 2. Acute hepatitis with jaundice attributed to turmeric.(1)

A 35 year old man with chronic low back pain developed fatigue, low grade fever, nausea, vomiting followed by itching, dark urine, and jaundice having taken a dietary supplement of curcumin for the previous two months (Nature’s Lab: Curcumin C3 1,000 mg with BioPerine [black pepper: 5 mg]). He was found to be jaundiced with a total bilirubin of 12.5 mg/dL, ALT 2014 U/L, AST 796 U/L, and alkaline phosphatase 124 U/L (R value 43). His other medications included ibuprofen, “Move Free Joint Support” (glucosamine, chondroitin sulfate and Boswellia), collagen powder, fish oil, vitamins B and C, and a daily multivitamin, all of which he had taken for 9 months or more. He was admitted for evaluation and management. Tests for hepatitis A, B, and C were negative. The ANA was positive (1:160), but SMA and AMA were negative. An ultrasound was normal. Despite discontinuation of the curcumin and treatment with methylprednisolone for 6 days, he remained jaundiced. A liver biopsy showed marked portal and lobular inflammation with lymphocytes and eosinophils but scant plasma cells. He was discharged and followed as an outpatient on antihistamines and cholestyramine for pruritus. Serum enzymes and bilirubin levels gradually decreased and fell into the normal range two months after initial presentation. When seen in follow up 1 year after onset, he was asymptomatic, and all liver tests were normal.

#### Key Points

Medication: | Curcumin (1,000 mg once daily) with black pepper
Pattern: | Hepatocellular (R=43)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 months
Recovery: | Complete within 2 months
Other medications: | Chondroitin, glucosamine, Boswellia, fish oil, collagen, vitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Started curcumin (1000 mg daily with black pepper)
6 weeks | | Developed symptoms of fatigue, nausea
2 months | 0 | 2014 | 125 | 12.5 | Admitted, curcumin stopped
| 1 day | 1535 | 114 | 11.8 | Methylprednisolone, 6 days
6 weeks | 2 days | 1106 | 74 | 8.5
7 weeks | 12 days | 780 | 81 | 14.0
9 weeks | 14 days | 730 | 92 | 14.0 | Discharged
| 20 days | 486 | 75 | 9.7
| 4 weeks | 795 | 69 | 5.2
| 5 weeks | 313 | 65 | 2.6
| 7 weeks | 52 | 51 | 1.8
| 2 months | 38 | 60 | 1.7
| 1 year | 16 | 54 | 1.3 | Final follow up
Upper Limit of Normal | | 50 | 125 | 1.2

#### Comment

A young man started an herbal supplement with high levels of curcumin (1 gram) and black pepper (5 mg) and developed a moderately severe acute hepatitis with jaundice two months later. He had some features of autoimmunity and was treated with methylprednisolone but had little or no response and the corticosteroid was stopped. Eventually he began to improve on his own, symptoms resolved, and liver tests fell into the normal range by 2 months after stopping the supplement. The curcumin product was tested chemically and found to contain both curcumin and black pepper as labelled; no other herbal product or toxin was identified. The patient had some features of autoimmunity (ANA positivity) but the liver biopsy was more compatible with drug induced liver injury, and he didn’t improve during a short trial of corticosteroids. Subsequent testing revealed that he was heterozygous for HLA- B*35:01, an allele strongly associated with hepatic injury caused by herbals that are rich in polyphenols (such as turmeric, green tea, polygonum multiflora, and garcinia).

### Case 3. Fatal case of acute liver injury attributed to turmeric.(1)

A 62 year old woman developed fatigue and nausea followed by dark urine and jaundice having taken a turmeric root extract (Rite Aid: Turmeric, 500 mg) once daily for wellbeing and arthritis for the previous 14 months. She had no history of liver disease, excessive alcohol intake, or risk factors for viral hepatitis. Her medical conditions included osteoarthritis, season allergies, menopausal symptoms, and uterine fibroids. Her medications included estrogens, pseudoephedrine, diphenhydramine, salbutamol, tramadol, magnesium, fish oil, ginger, glucosamine, vitamins C and D, and a multivitamin, all of which she had taken for more than a year. She stopped the turmeric and 3 days later was seen and found to have abnormal liver tests (bilirubin 2.5 mg/dL, ALT 1230 U/L, AST 1628 U/L, alkaline phosphatase 329 U/L). She was admitted to the hospital briefly. Tests for hepatitis A, B, C and E and for CMV and HSV infection were negative as were routine autoantibody and serum IgG levels. She was discharged and followed as an outpatient, but her condition worsened with bilirubin rising to 13.5 mg/dL and INR to 2.0. She was readmitted. Imaging of the liver showed evidence of diffuse hepatocellular disease, a nodular liver, and ascites. She was listed for emergency liver transplantation but suffered an acute myocardial infarction and ultimately developed multiorgan failure and died one month after initial presentation. An autopsy showed a shrunken liver, massive hepatic necrosis, a ruptured posterior leaflet of the mitral value, and recent myocardial infarction.

#### Key Points

Medication: | Turmeric 500 mg daily
Pattern: | Hepatocellular (R=14)
Severity: | 5+ (death within six months of onset from acute liver failure)
Latency: | 14 months
Recovery: | None
Other medications: | Estrogens, pseudoephedrine, diphenhydramine, salbutamol, tramadol, fish oil, magnesium, glucosamine, ginger, vitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | INR | Other
0 | | Started Turmeric (500 mg daily)
14 months | 0 | Curcumin stopped, symptoms of fatigue and jaundice
| 3 days | 1230 | 329 | 2.5 | | Admitted
| 7 days | 1360 | 333 | 6.1 | | Methylprednisolone, 6 days
| 10 days | 1277 | 311 | 8.6 | 1.5 | Discharged
| 13 days | 1088 | 251 | 13.5 | 2.0
| 17 days | 898 | 329 | 17.5 | 1.4 | Readmission
| 19 days | 704 | 303 | 18.7 | 2.3
15 months | 20 days | 513 | 249 | 16.8 | 2.1 | Acute myocardial infarction
| 22 days | 530 | 280 | 23.6 | 2.3
| 26 days | 171 | 160 | 22.8 | 2.5 | Listed for liver transplantation
| 33 days | | | | | Died of multiorgan failure
Upper Limit of Normal | | 35 | 135 | 1.2

#### Comment

A 62 year old woman developed a severe acute hepatitis 14 months after starting turmeric. No other cause for the liver injury was identified. The liver injury did not improve with stopping turmeric and within 3 weeks she demonstrated evidence of acute liver failure. She was listed for liver transplantation but developed an acute myocardial infarction and rapidly developed multiorgan failure and died within 5 weeks of onset. Chemical analysis was done on the herbal product which demonstrated the presence of turmeric without black pepper or other potentially hepatotoxins or herbs. The patient was negative for HLA-B*35:01. The case was judged to be only “probable” liver injury due to turmeric. Against the diagnosis was the long latency (greater than a year), lack of improvement with stopping the herbal product, and absence of HLA-B*35:01.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Turmeric – Generic

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING

Fact Sheet at National Center for Complementary and Integrative Health (https://www.nccih.nih.gov/health/turmeric)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Turmeric | 458-37-7 | C21-H20-O6

## CITED REFERENCE

1 Halegoua-DeMarzio D, Navarro V, Ahmad J, Avula B, Barnhart H, Barritt AS, Bonkovsky HL, et al. Liver injury associated with turmeric-a growing problem: ten cases from the Drug-Induced Liver Injury Network [DILIN]. Am J Med. 2023;136:200-206.36252717

## ANNOTATED BIBLIOGRAPHY

References updated: 16 June 2025

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; turmeric and curcumin are not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; turmeric and curcumin are not discussed).
Turmeric. In, PDR for herbal medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 864-7. (Compilation of short monographs on herbal medications and dietary supplements).
Stedman C. Herbal hepatotoxicity. Semin Liver Dis 2002; 22: 195-206. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; no mention of curcumin). 12016550
De Smet PAGM. Herbal remedies. N Engl J Med 2002; 347: 2046-56. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity, and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort, but not curcumin). 12490687
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Comprehensive review of herbal associated hepatotoxicity; curcumin is not listed as causing hepatotoxicity). 12879994
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to curcumin or turmeric use). 15390328
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, but none were attributed to turmeric or curcumin). 19159172
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were linked to turmeric or curcumin use). 18955056
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry, none of which were attributed to turmeric or curcumin). 19650152
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; curcumin is not listed as a potentially hepatotoxic botanical). 19826971
Wongcharoen W, Jai-Aue S, Phrommintikul A, Nawarawong W, Woragidpoonpol S, Tepsuwan T, Sukonthasarn A, et al. Effects of curcuminoids on frequency of acute myocardial infarction after coronary artery bypass grafting. Am J Cardiol 2012; 110: 40-4. (Among 121 Thai patients who were undergoing coronary artery bypass surgery treated with “curcuminoids” or placebo for 8 days perioperatively, rates of postoperative myocardial infarction were less with curcuminoids [13% vs 30%] as were ALT elevations above 3 times ULN [0% vs 3%]). 22481014
Dulbecco P, Savarino V. Therapeutic potential of curcumin in digestive diseases. World J Gastroenterol 2013; 19: 9256-70. (Review of pharmacokinetics, physical and molecular properties and potential uses of curcumin in digestive diseases; mentions that “as curcumin is particularly concentrated in the human liver, the risk of hepatotoxicity has been closely evaluated, but liver function tests have been shown to be unaffected with doses as high as 2 to 4 g/d”). 24409053
Meng B, Li J, Cao H. Antioxidant and antiinflammatory activities of curcumin on diabetes mellitus and its complications. Curr Pharm Des 2013; 19: 2101-13. (Review of the in vivo and in vitro evidence of antioxidant and antiinflammatory activity of curcumin and the rationale for its use in diabetes; “and it has no known side effects”). 23116316
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury; does not discuss curcumin or turmeric). 23121117
Sanmukhani J, Satodia V, Trivedi J, Patel T, Tiwari D, Panchal B, Goel A, et al. Efficacy and safety of curcumin in major depressive disorder: a randomized controlled trial. Phytother Res 2014; 28: 579-85. (Among 60 patients with major depression treated with fluoxetine or curcumin or both for 6 weeks, improvements in depression rating scales were similar in all 3 groups and “there was no significant difference in … laboratory tests … from baseline”). 23832433
Kuptniratsaikul V, Dajpratham P, Taechaarpornkul W, Buntragulpoontawee M, Lukkanapichonchut P, Chootip C, Saengsuwan J, et al. Efficacy and safety of Curcuma domestica extracts compared with ibuprofen in patients with knee osteoarthritis: a multicenter study. Clin Interv Aging 2014; 9: 451-8. (Among 367 adults with knee osteoarthritis treated with ibuprofen [1.2 g daily] or curcumin extracts [1.5 g daily] for 4 weeks, pain, stiffness and function scores improved equally in both groups and adverse event rates were similar [36% vs 30%]; no mention of ALT elevations or hepatotoxicity). 24672232
Rahmani S, Asgary S, Askari G, Keshvari M, Hatamipour M, Feizi A, Sahebkar A. Treatment of non-alcoholic fatty liver disease with curcumin: a randomized placebo-controlled trial. Phytother Res 2016; 30: 1540-8. (Among 80 Iranian patients with nonalcoholic fatty liver disease treated with curcumin [500 mg once daily] or placebo for 8 weeks, improvements, as assessed by ultrasonography, were more frequent with curcumin [79% vs 28%], and it was well tolerated with no serious adverse events and mean ALT levels decreased more with curcumin [from 39 to 36 U/L] than placebo [30 to 29 U/L]). 27270872
Panahi Y, Kianpour P, Mohtashami R, Jafari R, Simental-Mendía LE, Sahebkar A. Efficacy and safety of phytosomal curcumin in non-alcoholic fatty liver disease: a randomized controlled trial. Drug Res (Stuttg) 2017; 67(4): 244-51. (Among 102 patients with nonalcoholic fatty liver disease treated with curcumin [500 mg twice daily] or placebo for 8 weeks, improvements as assessed by hepatic ultrasound were more frequent with curcumin [75% vs 5%] and mean ALT levels fell from 35 to 25 U/L; there were no serious adverse events). 28158893
Mirzaei H, Shakeri A, Rashidi B, Jalili A, Banikazemi Z, Sahebkar A. Phytosomal curcumin: A review of pharmacokinetic, experimental and clinical studies. Biomed Pharmacother 2017; 85: 102-12. (Review of the chemical characteristics, in vitro antioxidant activity and clinical effects of phytosomal curcumin; mentions that “curcumin is safe and could be tolerated even at very high doses”). 27930973
Nelson KM, Dahlin JL, Bisson J, Graham J, Pauli GF, Walters MA. The essential medicinal chemistry of curcumin. J Med Chem 2017; 60: 1620-37. (Review of the pharmacology and clinical evidence for efficacy of curcumin concludes that the multiple in vitro effects represent assay interference, that it is poorly absorbed and that there is no evidence that it has any effect in humans despite claims for benefit in many conditions including erectile dysfunction, hirsutism, baldness, cancer, and Alzheimer disease). 28074653
Farzaei MH, Zobeiri M, Parvizi F, El-Senduny FF, Marmouzi I, Coy-Barrera E, Naseri R, et al. Curcumin in liver diseases: a systematic review of the cellular mechanisms of oxidative stress and clinical perspective. Nutrients 2018; 10: 855. (Review of the in vitro and in vivo results showing activity of curcumin in decreasing oxidative stress and summary of clinical studies demonstrating efficacy in liver disease). 29966389
Saadati S, Hatami B, Yari Z, Shahrbaf MA, Eghtesad S, Mansour A, Poustchi H, et al. The effects of curcumin supplementation on liver enzymes, lipid profile, glucose homeostasis, and hepatic steatosis and fibrosis in patients with non-alcoholic fatty liver disease. Eur J Clin Nutr 2019; 73: 441-9. (Among 50 patients with nonalcoholic liver disease given lifestyle advice and either curcumin [1500 mg] or placebo daily for 12 weeks, there were no differences between the two groups in weight loss [-2.4 vs -3.9 kg], changes in ALT [-6 vs -7 U/L] or in controlled attenuation parameter score for hepatic steatosis [-16 vs -32 dB/m]). 30610213
Lukefahr AL, McEvoy S, Alfafara C, Funk JL. Drug-induced autoimmune hepatitis associated with turmeric dietary supplement use. BMJ Case Rep 2018; 2018: bcr2018224611. (71 year old woman developed serum ALT elevations without jaundice 8-10 months after starting turmeric [ALT ~325 U/L, Alk P, and bilirubin normal; ANA 1:320], which gradually fell into the normal range after stopping). 30206065
Luber RP, Rentsch C, Lontos S, Pope JD, Aung AK, Schneider HG, Kemp W, et al. Turmeric induced liver injury: a report of two cases. Case Reports Hepatol 2019; 2019: 6741213. (A 52year old woman and 55 year old man developed evidence of liver injury 1 and 5 months after starting a turmeric supplement [bilirubin 9.5 and 1.3 mg/dL, ALT 2591 and 1149 U/L, Alk P 263 and 145 U/L], which resolved on stopping and recurred in the first patient on restarting the supplement [bilirubin 3.5 mg/dL, ALT 2093 U/L], which was tested and found free of adulterants). 31214366
Imam Z, Khasawneh M, Jomaa D, Iftikhar H, Sayedahmad Z. Drug induced liver injury attributed to a curcumin supplement. Case Rep Gastrointest Med. 2019;2019:6029403. (A 78 year old woman with diabetes developed jaundice one month after starting curcumin for hypercholesterolemia [bilirubin 12.8 mg/dL, ALT 609 U/L, Alk P 171 U/L, INR 1.1, ANA 1:320, IgG 951], which resolved on stopping and all liver tests were normal 2 months later). 31781418
Suhail FK, Masood U, Sharma A, John S, Dhamoon A. Turmeric supplement induced hepatotoxicity: a rare complication of a poorly regulated substance. Clin Toxicol (Phila) 2020; 58: 216-7. (61 year old woman with polycystic liver disease developed fatigue and dark urine 6 weeks after starting turmeric supplements [bilirubin total 1.6, direct 1.0, ALT 2607 U/L, Alk P 246 U/L, ANA 1:250 normal IgG levels], responding rapidly to a course of prednisone and tests remaining normal after stopping). 31271321
Donelli D, Antonelli M, Firenzuoli F. Considerations about turmeric-associated hepatotoxicity following a series of cases occurred in Italy: is turmeric really a new hepatotoxic substance? Intern Emerg Med 2020; 15: 725-6. (Letter mentioning an outbreak of acute cholestatic hepatitis in Italy related to use of a turmeric based dietary supplement with high bioavailability, perhaps due to its combination with piperine [black pepper] which increases curcumin absorption). 31278559
Chand S, Hair C, Beswick L. A rare case of turmeric-induced hepatotoxicity. Intern Med J 2020; 50: 258-9. (62 year old white woman developed fatigue, rash, and jaundice 10 months after starting turmeric [bilirubin >17 mg/dL, ALT 2308 U/L, Alk P not provided, ANA negative, IgG 1670 mg/dL], improving rapidly upon stopping the herbal supplement). 32037709
Nouri-Vaskeh M, Malek Mahdavi A, Afshan H, Alizadeh L, Zarei M. Effect of curcumin supplementation on disease severity in patients with liver cirrhosis: a randomized controlled trial. Phytother Res 2020; 34: 1446-54. (Among 70 patients with cirrhosis treated with curcumin [1000 mg daily] or placebo for 3 months, those on curcumin had improvements in MELD scores [INR decreasing from 1.57 to 1.49 and bilirubin from 2.5 to 2.1], while those on placebo worsened). 32017253
Lee BS, Bhatia T, Chaya CT, Wen R, Taira MT, Lim BS. Autoimmune hepatitis associated with turmeric consumption. ACG Case Rep J 2020; 7: e00320. (55 year old woman developed jaundice 3 months after starting Quinol Liquid Turmeric [15 mL daily] [bilirubin 11.8 mg/dL, ALT 2743 U/L, Alk P 204 U/L, INR 1.0, ANA 1:80 rising to 1:320], biopsy showing interface hepatitis and plasma cells, and she rapidly improved once turmeric was stopped). 32337301
Lombardi N, Crescioli G, Maggini V, Ippoliti I, Menniti-Ippolito F, Gallo E, Brilli V, et al. Acute liver injury following turmeric use in Tuscany: An analysis of the Italian Phytovigilance database and systematic review of case reports. Br J Clin Pharmacol 2021; 87: 741-53. (Analysis of the Italian Phytovigilance system identified 37 cases of liver injury attributed to high bioavailability curcumin; 7 cases reported from Tuscany included 6 women and 1 man, ages 45 to 68 years, taking turmeric for 2 weeks to 8 months [bilirubin 6 to 25 mg/dL, ALT 257 to 3303 U/L, GGT 124 to 504 U/L]; follow up after discontinuation was not always available). 32656820
Abdallah MA, Abdalla A, Ellithi M, Abdalla AO, Cunningham AG, Yeddi A, Rajendiran G. Turmeric-associated liver injury. Am J Ther 2020; 27: e642-e645. (51 year old white woman developed jaundice 2 months after starting a turmeric supplement [500 mg daily] [bilirubin total 2.4, direct 0.9 mg/dL, ALT 2484 U/L, Alk P 226 U/L], biopsy showing portal infiltrates including eosinophils, with rapid improvement upon stopping and normal liver tests 8 weeks later). 31283536
Koenig G, Callipari C, Smereck JA. Acute liver injury after long-term herbal "liver cleansing" and "sleep aid" supplement use. J Emerg Med. 2021;60:610-614. (53 year old woman developed jaundice 3-4 weeks after starting 2 herbal supplements, “Liver Detoxifier” which has 16 ingredients including turmeric and “Restful Sleep” with 5 components including valerian and melatonin [bilirubin 25.4 mg/dL, ALT 89 U/L, Alk P 174 U/L, albumin 2.0, INR 1.4], with rapid improvement on stopping). 33579656
Knox C, Bertouch J, Almeida J. Turmeric hepatotoxicity, cause or coincidence? Intern Med J. 2021;51:153. (Letter in response to Chand [2020] requesting more information about the dose and other ingredients in the turmeric supplement). 33572032
Sohal A, Alhankawi D, Sandhu S, Chintanaboina J. Turmeric-induced hepatotoxicity: report of 2 cases. Int Med Case Rep J. 2021;14:849-852. (Two cases, 57- and 53-year old women developed symptoms of liver injury 3 and ~2 months after starting turmeric [bilirubin 8.6 and 1.8 mg/dL, ALT 1414 and 733 U/L, Alk P not given, INRs normal], resolving within 2 and 1 months of stopping the supplement). 34992472
Sunagawa SW, Houlihan C, Reynolds B, Kjerengtroen S, Murry DJ, Khoury N. Turmeric-associated drug-induced liver injury. ACG Case Rep J. 2022;9:e00941. (49 year old woman developed jaundice 6 weeks after starting turmeric with black pepper [bilirubin 7.1 mg/dL, ALT 3289 U/L, Alk P 138 U/L, INR normal], resolving within 71 days of stopping the supplement). 36600786
Eghbali A, Nourigheimasi S, Ghasemi A, Afzal RR, Ashayeri N, Eghbali A, Khanzadeh S et al. The effects of curcumin on hepatic T2*MRI and liver enzymes in patients with β-thalassemia major: a double-blind randomized controlled clinical trial. Front Pharmacol. 2023;14:1284326. (Among 158 patients [above the age of 5] with beta-thalassemia treated with curcumin [500 mg] or placebo twice daily for 6 months, serum ALT levels decreased in those on curcumin [~152 to 105 U/L vs ~152 to 156 U/L], while Alk P levels rose and direct bilirubin levels decreased slightly in both groups; no patient reported any specific side effects from curcumin consumption and “all patients tolerated the capsules well in general.”). 38164474
Halegoua-DeMarzio D, Navarro V, Ahmad J, Avula B, Barnhart H, Barritt AS, Bonkovsky HL, et al. Liver injury associated with turmeric-a growing problem: ten cases from the Drug-Induced Liver Injury Network [DILIN]. Am J Med. 2023;136:200-206. (Ten cases of turmeric-associated liver injury presenting between 2011 and 2022 in the US, all adults [ages 35-71 years], mostly women [80%] and white [90%], with hepatocellular injury [90%], jaundice [50%], and 1 fatality; median ALT 1140 U/L, Alk P 164 U/L, bilirubin 2.5 mg/dL, and a strong association with HLA-B*35:01 [70% vs 12% in controls]). 36252717
Smith DN, Pungwe P, Comer LL, Ajayi TA, Suarez MG. Turmeric-associated liver Injury: a rare case of drug-induced liver injury. Cureus. 2023;15:e36978. (62 year old woman developed jaundice 3 weeks after starting turmeric tea [bilirubin 13.9 mg/dL, ALT 1889 U/L, Alk P 134 U/L, INR normal], with resolution within a month of stopping). 37139288
Ajitkumar A, Mohan G, Ghose M, Yarrarapu S, Afiniwala S. Drug-Induced liver injury secondary to turmeric use. Eur J Case Rep Intern Med. 2023;10:003845. (55 year old woman developed jaundice 1 month after starting 1500 mg of a turmeric supplement daily [bilirubin 8.1 mg/dL, ALT 2143 U/L, Alk P 590 U/L, INR 1.2] who was treated with intravenous N-acetyl cysteine and resolved the injury within 2 months of stopping the supplement). 37205206
Arzallus T, Izagirre A, Castiella A, Torrente S, Garmendia M, Zapata EM. Drug induced autoimmune hepatitis after turmeric intake. Gastroenterol Hepatol. 2023;46:805-806. (28 year old man developed jaundice 5 months after starting turmeric [bilirubin 7.3 mg/dL, ALT 3770 U/L, Alk P 200 U/L, ANA 1:160, IgG 823 mg/dL, HLA-B*35:01 positive], and treated with prednisone and azathioprine and eventually had normal liver tests apparently off of immunosuppression). 36634868
Foxon F. How prevalent is liver injury attributed to turmeric? Am J Med. 2024;137:e18. (Letter in response to Halegoua-DeMarzio [2023] suggesting that turmeric-associated liver injury is very rare and not likely to be increasing in frequency, because turmeric has been used for centuries, although not as purified curcumin extracts). 38061832
Haloub K, McNamara E, Yahya RH. An unusual case of dietary-induced liver Injury during pregnancy: a case report of probable liver injury due to high-dose turmeric intake and literature review. Case Reports Hepatol. 2024;2024:6677960. (A pregnant woman developed pruritus during the 23rd week of pregnancy and while taking turmeric [bilirubin 0.2 mg/dL, ALT 734 U/L, Alk P 175 U/L] and improved with stopping turmeric and starting ursodiol, but presented again at 35 weeks with pruritus [bilirubin 0.2 mg/dL, ALT 51 U/L, Alk P 256 U/L, and elevated bile acids], which was interpreted as idiopathic cholestasis of pregnancy and resolved after delivery). 38352658
Alghzawi F, Jones R, Haas C. Turmeric-induced liver injury. J Commun Hosp Intern Med Perspectives. 2024;14:55-59. Not in PubMed. (66 year old woman developed elevated enzymes [bilirubin 0.7 mg/dL, ALT 275 U/L, Alk P 178 U/L] 1 month after starting a locally prepared ground turmeric which was stopped but later restarted and she developed jaundice 5 months later [bilirubin 29 mg/dL, ALT 738 U/L, Alk P 397 U/L, INR 1.8] which was rapidly followed by hepatic failure and death from multiorgan failure). 39036565
Carty J, Navarro VJ. Dietary supplement-induced hepatotoxicity: A clinical perspective. J Diet Suppl. 2025;22:58-77. (Review of the challenges, diagnosis, and clinical management of liver injury due to HDS including anabolic steroids, aegeline, ashwagandha, ephedra, garcinia, green tea, kratom, and turmeric, mentions that turmeric typically causes hepatocellular injury arising after 1-4 months of therapy). 38528750
Philips CA, Theruvath AH. A comprehensive review on the hepatotoxicity of herbs used in the Indian (Ayush) systems of alternative medicine. Medicine (Baltimore). 2024;103:e37903. (Extensive review of recent literature on traditional Indian herbs that have been linked to cases of liver injury including Curcuma longa [Turmeric], mentions that curcumin is a pan-assay interference compound the causes it to show bioactivity in multiple assays, but that it is also poorly absorbed and rapidly excreted, for which reason concentrated forms with altered means of absorption have been developed which may explain the recent increase in reports of liver injury with its use). 38640296
Likhitsup A, Chen VL, Fontana RJ. Estimated exposure to 6 potentially hepatotoxic botanicals in US adults. JAMA Netw Open. 2024;7:e2425822. (Analysis of the 9685 adults enrolled in the U.S. National Health and Nutrition Examination Survey between 2017 and 2020, found that 58% used herbal or dietary supplements, the most commonly used botanical product being turmeric [n= 256, 2.6%] followed by green tea [92, 0.9%], ashwagandha [28, 0.3%], Garcinia [20, 0.2%], red yeast rice [20, 0.2%] and black cohosh [19, 0.2%]). 39102266
Patel R, Hassan A, Scanlan H, Everwine M, Ren Z, Snyder C, ElGenaidi H. Acute liver failure induced by provitalize: a menopause supplement concocted from herbs & probiotics. ACG Case Rep J. 2024;11:e01509. (49 year old woman developed jaundice 1 month after starting a menopausal supplement containing turmeric root extract with probiotics, moringa, and black pepper [bilirubin 8.8 mg/dL, ALT 3008 U/L, Alk P 195 U/L, INR 2.0] with progressive liver failure and death while awaiting liver transplantation). 39310049
Abboud A, Ullah K, Klyachman L, Huang EB, Cherala R. Turmeric-induced liver injury. J Brown Hosp Med. 2024;3:21-24. (53 year old woman with Behcet disease developed fatigue and dark urine 4 months after starting a Kirkland turmeric supplement [bilirubin normal, ALT 1560 U/L, Alk P 149 U/L, INR normal] with improvement starting 6 days after stopping, all liver tests returning to normal within 4 months). 40026546
Garaizabal Azkue ÍJ, Castiella A, Aburruza Ucar L, Torrente Iranzo S, Zapata Morcillo E. Turmeric associated liver injury (DILI) with susceptible HLA. Rev Esp Enferm Dig. 2024;116:650-651. (35 year old woman developed jaundice 2 months after starting a turmeric and black pepper containing supplement [bilirubin 10.5 mg/dL, ALT 2230 U/L, Alk P not provided, HLA-B*35:01 positive] with rapid improvement on stopping). 39297606
Kim SK, Jayachandran V, Vo TS, Wijesekara I. Safety assessment of turmeric-boswellia-sesame formulation in healthy adult volunteers: an open-label prospective study. Adv Clin Exp Med. 2025 Jan 8. Epub ahead of print. (Open label study of a supplement containing turmeric [532 mg curcuminoids] and boswellia [20 mg] twice daily for 90 days in 40 healthy adults found no evidence of adverse events or cases of acute liver injury or elevations in serum ALT levels above baseline). 39778015
Papke DJ Jr, Viveiros K, Zota V, Gill RM, González IA, Misdraji J, Patil DT. Turmeric supplement-associated hepatitis: a clinicopathological series of 11 cases highlighting pan-lobular and zone 3 injury. Histopathology. 2025;86:410-422. (Review of a pathology archives from 5 US medical centers identified 11 cases of liver injury possibly due to turmeric, 7 were symptomatic, 5 jaundiced, none died, most had acute, hepatocellular injury). 39381846
Shrestha A, Elliott S, Abasszade JH, Wu K, Worland T, Simpson I, Dev A. Drug-induced liver injury associated with turmeric and piperine: a case and review. Case Rep Gastroenterol. 2025;19:96-106. (40 year old woman developed fatigue and dark urine 5 months after starting a self-made concoction of ground turmeric and black pepper [bilirubin 5.8 mg/dL, ALT 2519 U/L, Alk P 107 U/L, ANA 1:320] responding to discontinuation and prednisolone). 39995754
Halegoua-DeMarzio D, Navarro V. Challenges in herbal-induced liver injury identification and prevention. Liver Int. 2025;45:e16071. (Review of the continuing rise in cases of herbal supplement induced liver injury in the United States mentions that turmeric is one of the commonly implicated ingredients that typically causes self-limited hepatocellular injury which can be severe and even fatal and is associated the B*35:01 HLA allele). 39136211

## OTHER REFERENCE LINKS

Recent References on Turmeric: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?term=turmeric)

Trials on Turmeric: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?cond=turmeric&term=&cntry=&state=&city=&dist=)